# Belzutifan

## OVERVIEW

### Introduction

Belzutifan is a small molecule inhibitor of hypoxia-inducible factor 2 alpha used to treat solid tumors in patients with von Hippel-Lindau disease. Belzutifan is associated with a low rate of minor serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury.

### Background

Belzutifan (bel zue’ ti fan) is an oral small molecule inhibitor of hypoxia-inducible factor 2 alpha (HIF-2α) which is elevated in tumors of patients with von Hippel-Lindau (VHL) disease. HIF is a regulator of oxygen homeostasis that has an oxygen-sensitive subunit (2α) and a constitutively expressed subunit (1β). With normal oxygen levels, HIF-2α is hydroxylated and binds to the VHL tumor suppressor protein which promotes its ubiquitin-targeted proteasomal degradation. With low levels of oxygen, HIF-2α binds to HIF-1β creating a transcription complex that stimulates hypoxia-inducible gene transcription, including genes for erythropoiesis, angiogenesis and cellular proliferation which can promote cancer cell growth. Patients with VHL disease have a defective protein that does not bind HIF-2α, leaving it free to bind HIF-1β and increase transcriptions of genes of angiogenesis and tumor cell growth. As a result, patients with VHL disease are at high risk of developing tumors including clear cell renal cell carcinoma, hemangioblastomas of the central nervous system (CNS) and retina, cystadenomas, and pancreatic neuroendocrine tumors. These tumors are generally slow growing and metastasize late, so that surgery is recommended only when they achieve a certain size or are symptomatic. In open label studies in patients with VHL disease and clear cell renal cell cancer, CNS hemangioblastomas or pancreatic neuroendocrine tumors, treatment with belzutifan resulted in a decrease in the size or retardation of growth (stable disease) of tumors in a high proportion of patients. Belzutifan was approved in the United States in 2021 for treatment of patients with tumors related to VHL disease not requiring immediate surgery. It is still being evaluated as therapy of patients with VHL disease who have cancers with acquired defects in the VHL gene. Belzutifan is available in tablets of 40 mg under the brand name Welireg. The recommended dose is 120 mg daily until disease progression or unacceptable toxicity. Side effects are common but usually do not require dose modification. The most common adverse events are anemia, fatigue, headache, dizziness, nausea, dyspnea, arthralgia, myalgia and increases in creatinine and glucose levels. Patients treated with belzutifan should be monitored for oxygen saturation and with blood tests for hemoglobin, creatinine, and glucose. Uncommon, but potentially severe adverse events include life-threatening anemia, severe hypoxia, and embryo-fetal toxicity.

### Hepatotoxicity

In the preregistration trials of belzutifan, serum aminotransferase elevations occurred in up to 20% of patients, but were invariably transient and mild (less than 3 times ULN) and were not accompanied by symptoms or jaundice. No patient required dose modification or discontinuation because of liver test abnormalities. Furthermore, since its more widespread use after its approval, there have been no published reports of clinically apparent liver injury attributed to belzutifan.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why belzutifan might cause serum enzyme elevations is not known, but it is metabolized in the liver by the cytochrome P450 system (predominantly CYP 2C19 and to a lesser extend 3A4) and liver injury may be the result of production of a toxic or immunogenic metabolic intermediate. Belzutifan is potentially susceptible to drug-drug interactions with agents that are substrates of CYP 3A4 or inhibit CYP 2C19.

### Outcome and Management

Serum enzyme elevations are not uncommon during belzutifan therapy but rarely require dose modification or drug discontinuation. As with any drug, belzutifan should be held if ALT or AST values rise above 5 times the ULN and discontinued if elevations are more than 20 times the ULN or jaundice or symptoms of liver injury arise.

Drug Class: Antineoplastic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Belzutifan – Welireg®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Belzutifan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Belzutifan | 1672668-24-4 | C17-H12-F3-NO4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2023

Abbreviations used: HIF, hypoxia inducible factor; VHL, von Hippel-Lindau.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of belzutifan).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 does not discuss belzutifan).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1203-36. (Textbook of pharmacology and therapeutics).
Jonasch E, Donskov F, Iliopoulos O, Rathmell WK, Narayan VK, Maughan BL, Oudard S, et al.; MK-6482-004 Investigators. Belzutifan for renal cell carcinoma in von Hippel-Lindau disease. N Engl J Med. 2021;385:2036-2046. (Among 61 patients with VHL disease and renal cell cancer treated with belzutifan [120 mg daily] for 20-30 months, half had confirmed partial responses and the 24 month progression-free survival was 96%, while adverse event rate was 100%, the most common adverse events being anemia [90%], fatigue [66%], headache [41%], and dizziness [39%], nausea [34%], dyspnea [23%], arthralgia [20%], resulting in drug interruption in 43%, dose reduction in 15% and discontinuation in 12%; ALT elevations arose in 16%, all were transient, asymptomatic and less than 3 times ULN and none required drug discontinuation). 34818478
Deeks ED. Belzutifan: first approval. Drugs. 2021 Nov;81(16):1921-1927. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of belzutifan soon after its approval by the FDA as therapy for solid tumors related to von Hippel-Lindau disease, mentions that 20% of patients developed ALT elevations, but there were no liver-related serious adverse events). 34613603
Dhawan A, Peereboom DM, Stevens GH. First clinical experience with belzutifan in von Hippel-Lindau disease associated CNS hemangioblastoma. CNS Oncol. 2022;11(3):CNS91. (Description of two patients with VHL disease and CNS hemangioblastoma who had clinical improvement and slight decrease in the size of the tumors with belzutifan therapy, with side effects of anemia but good tolerability; no mention of ALT elevations or hepatotoxicity). 35819008
Fallah J, Brave MH, Weinstock C, Mehta GU, Bradford D, Gittleman H, Bloomquist EW, et al. FDA Approval summary: belzutifan for von Hippel-Lindau disease-associated tumors. Clin Cancer Res. 2022;28:4843-4848. (Description of the basis for the FDA approval of belzutifan summarizing the clinical efficacy of treatment in reducing the size and rate of grown of renal cell carcinoma in patients with VHL disease and the safety assessment with no drug related deaths and frequent but acceptable adverse event rates; no mention of ALT elevations or hepatotoxicity). 35727604
Takamori H, Yamasaki T, Kitadai R, Minamishima YA, Nakamura E. Development of drugs targeting hypoxia-inducible factor against tumor cells with VHL mutation: Story of 127 years. Cancer Sci. 2023;114:1208-1217. (History of the development of belzutifan from the description of VHL disease by von Hippel [1904] and Lindau [1927] to the description of the gene mutated in VHL disease [1993], the association of HIF with VHL mutated protein [1999], the Nobel Prize award to scientists who discovered how cells adapt to oxygen availability [2019], and the approval of the first HIF inhibitor as effective therapy of VHL disease [2021]). 36650918
Shirole NH, Kaelin WG Jr. von-Hippel Lindau and hypoxia-inducible factor at the center of renal cell carcinoma biology. Hematol Oncol Clin North Am. 2023;37(5):809-825. (Review of the molecular role of HIF-α2 in tumorigenesis and development of inhibitors as therapy of tumors associated with von Hippel-Lindau disease). 37270382
Neth BJ, Webb MJ, White J, Uhm JH, Pichurin PN, Sener U. Belzutifan in adults with VHL-associated central nervous system hemangioblastoma: a single-center experience. J Neurooncol. 2023;164(1):239-247. (Among 4 women with VHL disease and craniospinal hemangioblastoma not amenable to surgery were treated with belzutifan for 6-17 months, all had a radiographic response, while adverse events included anemia, dizziness, nausea, and fatigue, none requiring dose modification; no mention of ALT elevations). 37450072

## OTHER REFERENCE LINKS

Recent References on Belzutifan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Belzutifan/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

Trials on Belzutifan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Belzutifan)